# Tigecycline

## OVERVIEW

### Introduction

Tigecycline is an intravenously administered tetracycline antibiotic used for treatment of serious infections due to susceptible organisms. Tigecycline is frequently accompanied by mild to moderate serum aminotransferase elevations during intravenous therapy and has been implicated in rare cases of clinically apparent liver injury with jaundice.

### Background

Tigecycline (tye" ge sye' kleen) is a glycylcycline, a tetracycline antibiotic used for treatment of serious infections due to susceptible organisms. Like other tetracyclines, tigecycline is a broad spectrum bacteriostatic agent that acts by binding to bacterial ribosomes, inhibiting protein synthesis. Tigecycline has activity against both gram-positive and gram-negative bacteria and, importantly, it also has activity against many multidrug resistant organisms. Tigecycline was approved for use in the United States in 2005. Current indications include treatment of community acquired bacterial pneumonia, complicated skin and skin structure infections, and complicated intra-abdominal infections due to susceptible organisms. Tigecycline is available in vials of 50 mg for parenteral use under the brand name Tygacil. The recommended adult dose is 100 mg intravenously initially, followed by 50 mg every 12 hours for 5 to 14 days depending on the severity and site of the infection. A reduced dosage is recommended for patients with severe underlying liver disease. Because of its broad spectrum of activity, tigecycline is often reserved for patients with serious multidrug resistant infections and is recommended only for strongly suspected or proven susceptible bacteria. In 2010 an FDA analysis of randomized controlled trials suggested that tigecycline was associated with a higher mortality than comparator antibiotics. Several subsequent systematic reviews have reached conflicting conclusions. The higher mortality rate associated with tigecycline therapy does not seem to be due to adverse events, but rather lower success or cure rates. The most frequent side effects of tigecycline are diarrhea, nausea and vomiting, abdominal pain, and headache. Less common but potentially more severe adverse events include liver injury, pancreatitis, decreases in serum coagulation factors, inhibition of bone growth, tooth discoloration (in infants and children below the age of 9 years), and Clostridioides difficile-associated diarrhea. Use of tigecycline is not recommended for patients under the age of 18 years or in pregnant women in the 2^nd^ or 3^rd^ trimesters.

### Hepatotoxicity

Tigecycline therapy is reported to cause mild to moderate but transient elevations in serum aminotransferase levels in up to 33% of recipients. The rate of enzyme elevations is higher with longer courses of therapy and higher cumulative doses. Nevertheless, cases of clinically apparent liver injury with jaundice due to tigecycline are rare although fatal instances have been reported. Product labels for tigecycline mention isolated cases of significant hepatic dysfunction with cholestasis and jaundice identified from postmarketing experience. The latency, pattern, and duration of liver injury in cases of tigecycline induced hepatotoxicity are not well defined. From previous studies, standard tetracycline when given intravenously for more than a few days was associated with severe liver injury marked by macrovesicular steatosis, lactic acidosis, and hepatic failure. The clinical features resembled Reye syndrome and was considered due to direct hepatic mitochondrial injury and inhibition of protein synthesis. For this reason, intravenous tetracycline was withdrawn from use. The rare instances of severe hepatotoxicity reported from intravenous use of tigecycline have similar symptoms including hepatic steatosis and marked cholestasis. The presence of lactic acidosis has not been reported and detailed data on latency, dose of tigecycline, and course of the illness have been sparse. However, the intravenous use of second and third generation tetracyclines such as tigecycline, omadacycline, and eravacycline for more than 10 or 14 days should probably be avoided or patients monitored carefully for liver injury, hepatic steatosis, and acidosis. Intravenous tigecycline therapy has been associated with a decrease in serum albumin and coagulation factors, suggesting that it can cause inhibition of hepatic protein synthesis, and that evidence of direct hepatic injury might require a longer duration of therapy than has been typically used for tigecycline. Analyses of data collected by the FDA’s Adverse Event Reporting System (FAERS) suggested that both acute hepatocellular injury and acute liver failure have occurred with tigecycline therapy.

Likelihood score: B (likely cause of clinically apparent liver injury perhaps due to direct hepatotoxicity with longer [more than 10 days] courses of high-dose treatment).

### Mechanism of Injury

The cause of the serum enzyme elevations during intravenous therapy with tigecycline is unknown. High doses of intravenous tetracycline were associated with a severe direct hepatic injury marked by mitochondrial dysfunction. The severe liver injury from tigecycline, omadacycline, and eravacycline may share a similar mechanism.

Oral tetracyclines are also associated with rare instances of idiosyncratic liver injury with autoimmune features that generally arise with long term oral use and are most commonly associated with minocycline. Intravenous tigecycline, eravacycline, and omadacycline have not been linked to this form of liver injury. Tigecycline is minimally metabolized in the liver and most is excreted unchanged in the bile, feces, and urine, which may explain its relative lack of idiosyncratic, immune mediated hepatotoxicity.

### Outcome and Management

Patients with cirrhosis should be monitored during tigecycline therapy for evidence of worsening hepatic function. Patients on intravenous tigecycline who develop serum aminotransferase elevations that rise above 5 times the upper limit of normal or are accompanied by jaundice or symptoms should have tigecycline stopped. Whether there is cross-sensitivity to hepatic injury among the various tetracyclines is not known, but switching to another class of antibiotics would be more appropriate than changing to another tetracycline-like agent in patients who develop evidence of liver injury while receiving tigecycline.

Drug Class: Antiinfective Agents, Tetracyclines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tigecycline – Tygacil®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=tigecycline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tigecycline | 220620-09-7 | C29-H39-N5-O8

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2026

Abbreviations used: ULN, upper limit of normal; iv, intravenous; ANA, antinuclear antibody.

Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 589-637. (Expert review of liver injury due to antimicrobial agents published in 1999; tigecycline is not mentioned).
Moseley RH. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced Liver Disease. Second Edition. New York: Informa Healthcare, 2007, pp. 527-46. (Expert review of antibiotic induced liver injury published in 2007, mentions that tigecycline was only recently approved, is known to cause serum enzyme elevations, but has not been linked to cases of clinically apparent liver injury).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Knollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
Postier RG, Green SL, Klein SR, Ellis-Grosse EJ, Loh E; Tigecycline 200 Study Group. Results of a multicenter, randomized, open-label efficacy and safety study of two doses of tigecycline for complicated skin and skin-structure infections in hospitalized patients. Clin Ther 2004; 26: 704-14. (160 patients received tigecycline for 5 to 14 days; asymptomatic, self-limited ALT elevations occurred in 3%). 15220014
Babinchak T, Ellis-Grosse E, Dartois N, Rose GM, Loh E; Tigecycline 301 Study Group; Tigecycline 306 Study Group. The efficacy and safety of tigecycline for the treatment of complicated intra-abdominal infections: analysis of pooled clinical trial data. Clin Infect Dis 2005; 41 (Suppl 5): S354-67. (Summary of phase III trials comparing tigecycline [n=817] to imipenem/cilastatin [n=825] given for 5-14 days; ALT and AST elevations occurred in ~3% of both groups; one patient withdrew due to ”liver damage"). 16080073
Breedt J, Teras J, Gardovskis J, Maritz FJ, Vaasna T, Ross DP, Gioud-Paquet M, et al; Tigecycline 305 cSSSI Study Group. Safety and efficacy of tigecycline in treatment of skin and skin structure infections: results of a double-blind phase 3 comparison study with vancomycin-aztreonam. Antimicrob Agents Chemother 2005; 49: 4658-66. (Randomized controlled trial in 546 patients treated for up to 14 days; ALT and AST elevations occurred in 1-2% of tigecycline treated compared to 5-6% of comparative antibiotic treated patients). 16251309
Ellis-Grosse EJ, Babinchak T, Dartois N, Rose G, Loh E; Tigecycline 300 cSSSI Study Group; Tigecycline 305 cSSSI Study Group. The efficacy and safety of tigecycline in the treatment of skin and skin-structure infections: results of 2 double-blind phase 3 comparison studies with vancomycin-aztreonam. Clin Infect Dis 2005; 41 (Suppl 5): S341-53. (Summary of two phase III trials comparing tigecycline [n=566] to vancomycin/aztreonam [n=550] for up to 14 days; ALT and AST elevations reported in 1.4-1.8% of tigecycline treated and 5.1-6.2% of vancomycin/aztreonam treated patients; no hepatitis with jaundice). 16080072
Garrison MW, Neumiller JJ, Setter SM. Tigecycline: an investigational glycylcycline antimicrobial with activity against resistant gram-positive organisms. Clin Ther 2005; 27: 12-22. (Review article on tigecycline: “Mild elevations in liver function parameters and blood urea nitrogen were also observed but required no intervention.”). 15763603
Oliva ME, Rekha A, Yellin A, Pasternak J, Campos M, Rose GM, Babinchak T, et al; 301 Study Group. A multicenter trial of the efficacy and safety of tigecycline versus imipenem/cilastatin in patients with complicated intra-abdominal infections [Study ID Numbers: 3074A1-301-WW; ClinicalTrials.gov Identifier: NCT00081744]. BMC Infect Dis 2005; 5: 88. (Randomized controlled trial of tigecycline vs imipenem/cilastatin; no mention of clinically apparent liver injury or incidence of ALT elevations). 16236177
Rello J. Pharmacokinetics, pharmacodynamics, safety and tolerability of tigecycline. J Chemother 2005; 17 (Suppl 1): 12-22. (A summary of phase I, II and III studies of tigecycline; elevated ALT or AST levels reported in 1% to 2% of tigecycline recipients and higher proportion of patients receiving comparative antibiotics; no cases of hepatitis with jaundice attributable to tigecycline). 16285354
Rubinstein E, Vaughan D. Tigecycline: a novel glycylcycline. Drugs 2005; 65: 1317-36. (Review article on tigecycline reporting low rates of ALT and AST elevations [<2%] in phase III randomized controlled trials). 15977966
Sacchidanand S, Penn RL, Embil JM, Campos ME, Curcio D, Ellis-Grosse E, Loh E, Rose G. Efficacy and safety of tigecycline monotherapy compared with vancomycin plus aztreonam in patients with complicated skin and skin structure infections: Results from a phase 3, randomized, double-blind trial. Int J Infect Dis 2005; 9: 251-61. (Randomized controlled trial of tigecycline [n=292] vs vancomycin and aztreonam [n= 281] for up to 14 days; ALT and AST elevations occurred in 1-2% of tigecycline vs 5-6% of comparator recipients; no case of clinically apparent liver disease). 16099700
Tanaseanu C, Bergallo C, Teglia O, Jasovich A, Oliva ME, Dukart G, Dartois N, Cooper CA, Gandjini H, Mallick R; 308 Study Group; 313 Study Group. Integrated results of 2 phase 3 studies comparing tigecycline and levofloxacin in community-acquired pneumonia. Diagn Microbiol Infect Dis 2008; 61: 329-38. (Combined results of two clinical trials comparing tigecycline to levofloxacin in 846 patients with pneumonia found similar efficacy [74-86%]; nausea and vomiting were more common with tigecycline; ALT elevations occurred in 2.6% of tigecycline vs 6.4% of levofloxacin treated patients; no mention of hepatitis or jaundice). 18508226
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, minocycline accounted for 3 cases, doxycycline for 3 cases, tetracycline was listed as a secondary possible cause for one, but none were attributed to tigecycline). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 25 to antituberculosis agents, 9 to trimethoprim/sulfamethoxazole, 12 to nitrofurantoin, 2 to doxycycline, but none to minocycline or other tetracyclines). 20949552
Towfigh S, Pasternak J, Poirier A, Leister H, Babinchak T. A multicentre, open-label, randomized comparative study of tigecycline versus ceftriaxone sodium plus metronidazole for the treatment of hospitalized subjects with complicated intra-abdominal infections. Clin Microbiol Infect 2010; 16: 1274-81. (Controlled trial of tigecycline versus ceftriaxone/metronidazole in 376 patients with complicated intra-abdominal infections; no mention of ALT elevations or liver injury). 20670293
Tasina E, Haidich AB, Kokkali S, Arvanitidou M. Efficacy and safety of tigecycline for the treatment of infectious diseases: a meta-analysis. Lancet Infect Dis 2011; 11: 834-44. (Meta-analysis of 14 randomized controlled trials of tigecycline vs comparator antibiotic regimens found non-significantly lower success rates and higher adverse events in the tigecycline group, mostly due to nausea and vomiting; no discussion of ALT elevations or liver injury). 21784708
Bodmann KF, Heizmann WR, von Eiff C, Petrik C, Löschmann PA, Eckmann C. Therapy of 1,025 Severely Ill Patients with Complicated Infections in a German Multicenter Study: Safety Profile and Efficacy of Tigecycline in Different Treatment Modalities. Chemotherapy 2012; 58: 282-94. (Among 1025 patients with severe infections treated with tigecycline, 2.5% had serious adverse events mostly due to drug inefficacy or bacterial resistance; 1% had liver test elevations and the mortality rate was 20%, half due to multiorgan failure and 1.2% to hepatic failure). 23052187
Kadoyama K, Sakaeda T, Tamon A, Okuno Y. Adverse event profile of tigecycline: data mining of the public version of the U.S. Food and Drug Administration adverse event reporting system. Biol Pharm Bull. 2012; 35: 967-70. (Analysis of adverse event reports on tigecycline compared to other agents suggested increased rates of nausea, vomiting, pancreatitis, liver failure, ALT and Alk P elevations). 22687540
Prasad P, Sun J, Danner RL, Natanson C. Excess deaths associated with tigecycline after approval based on noninferiority trials. Clin Infect Dis 2012; 54: 1699-709. (Systematic analysis of 13 randomized controlled trials of tigecycline vs comparator antibiotic regimens in 7434 patients with severe infections found increased mortality [risk difference RD=0.7%] in tigecycline group and increased non-cure rates [RD=2.9%]). 22467668
Vardakas KZ, Rafailidis PI, Falagas ME. Effectiveness and safety of tigecycline: focus on use for approved indications. Clin Infect Dis 2012; 54: 1672-4. (A systematic review of randomized controlled trials of tigecycline vs comparator agents suggested that tigecycline was not associated with a higher mortality rate in patients with infections for which the agent is approved: 2.5% vs 1.8%, p=0.09). 22431809
Rossitto G, Piano S, Rosi S, Simioni P, Angeli P. Life-threatening coagulopathy and hypofibrinogenaemia induced by tigecycline in a patient with advanced liver cirrhosis. Eur J Gastroenterol Hepatol 2014; 26: 681-4. (A 43 year old woman with autoimmune hepatitis and advanced cirrhosis developed worsening jaundice, elevations in INR and fall in fibrinogen levels 5 days after starting tigecycline for a systemic infection, which then returned to baseline once tigecycline was stopped). 24667348
Zhang Q, Zhou S, Zhou J. Tigecycline treatment causes a decrease in fibrinogen levels. Antimicrob Agents Chemother 2015; 59: 1650-5. (Among 20 patients with severe infections who were monitored during tigecycline therapy, serum fibrinogen levels decreased in 19 and were associated with bleeding episodes in 6 patients, while mean ALT and bilirubin levels did not change and all abnormalities returned to baseline upon stopping tigecycline). 25547356
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. [PMC free article (https://www.ncbi.nlm.nih.gov/pmc/articles/PMC4446235/)] [] (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 28 [3%] to minocycline and 4 [0.4%] to doxycycline, but none to tigecycline) 25754159
Shi X, Zuo C, Yu L, Lao D, Li S, Xu Q, Lv Q. Real-world data of tigecycline-associated drug-Induced liver injury among patients in China: a 3-year retrospective study as assessed by the updated RUCAM. Front Pharmacol. 2021;12:761167. (Among 973 hospitalized patients treated with tigecycline over a 3 year period at a single Chinese referral hospital, 55 [6%] developed evidence of drug induced liver injury, of which 10% were hepatocellular, 42% associated with jaundice, 13% scored as severe, but none as fatal; risk factors of liver injury included duration and dose of therapy and concomitant use of other hepatotoxic agents suggesting direct hepatotoxicity). 34795591
Yu Z, Zhao Y, Jin J, Zhu J, Yu L, Han G. Prevalence and risk factors of tigecycline-induced liver injury: a multicentre retrospective study. International Journal of Infectious Diseases 2022; 120: 59-64. (Among 391 hospitalized patients treated with tigecycline for at least 7 days over a 2 year period at three Chinese medical centers, 41 developed evidence of drug induced liver injury [10%], most cases being cholestatic [n=35, 85%] and mild [n=35]; risk factors included abnormal baseline ALT, ICU admission, and duration of treatment, but not average daily dose). 35429639
Shi X, Lao D, Xu Q, Li X, Lv Q. A case report of drug-induced liver injury after tigecycline administration: histopathological evidence and a probable causality grading as assessed by the updated RUCAM diagnostic scale. BMC Infect Dis. 2022;22:368. (68 year old man with hemodynamic and infectious complications after liver transplantation for chronic hepatitis B and liver cancer, developed acute rises in liver tests [bilirubin 5.3 mg/dL, ALT 106 U/L, Alk P 374 U/L] 5 days after starting tigecycline, but also with sepsis and receiving polymyxin B, amikacin, and meropenem, resolving rapidly on stopping). 35410140
Jiang T, Huang X, Liu Q, Feng H, Huang Y, Lin J, Huang L, et al. Risk factors for tigecycline-associated hepatotoxicity in patients in the intensive care units of 2 tertiary hospitals: a retrospective study. J Clin Pharmacol. 2022;62:1426-1434. (Among 148 patients treated with tigecycline for at least 4 days in the ICU of 2 referral medical centers in China over a 6-year period, 50 [34%] developed “hepatotoxicity”, treatment duration being the major modifiable risk factor, with 11 days the optimal cutoff value to avoid liver injury). 35670488
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] over a 16 year period, identified 1435 cases of liver injury, the most being with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; tigecycline had the highest proportion of events being liver related and fatal). 35364753
Zhang Y, Wang J, Tan Y, Wu J. Acute liver failure caused by high dose tigecycline: a case report. Int J Clin Pharmacol Ther. 2024;62:339-344. (76 year old woman with subarachnoid hemorrhage developed ventilator associated pneumonia and was treated with high dose intravenous tigecycline [100 mg every 12 hours] for 15 days when she was found to have jaundice [bilirubin 9.1 mg/dL, ALT 15 U/L, Alk P 346 U/L], and had progressive hepatic failure [bilirubin rising above 30 mg/dL, INR 5.7] despite stopping tigecycline, dying of multiorgan failure 10 days later). 38606856
Turan Gökçe D, Arı D, Aydın O, Turhan N, Altunsoy A, Ökten RS, Akdoğan Kayhan M. Tigecycline-associated hepatic steatosis after liver transplant: a case report. Exp Clin Transplant. 2024;22:318-321. (Two women, ages 61 and 53 years, developed infections after liver transplantation and received tigecycline [100 mg once, then 50 mg twice daily iv for 6 and 16 days] and developed rising ALT and bilirubin levels, with liver biopsies a few days later showing marked macrovesicular fat, Mallory bodies, and canalicular cholestasis; the liver injury resolving after discontinuation). 38742325
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of drug-induced liver injury enrolled in a prospective Latin American database, 4 [0.9%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline, but none to tigecycline, eravacycline, omadacycline, or sarecycline). 38992407
Wang Y, Zhang S, Shen M, Zhang K. Risk factors for tigecycline-associated drug-induced liver injury in critically ill patients: a 2020-2023 retrospective study from a Chinese hospital. BMC Infect Dis. 2026 June 11. Epub ahead of print. (Among 309 critically ill adults who received iv tigecycline at a single referral hospital in China between 2021 and 2024, 71 [23%] developed biochemical evidence of liver injury, risk factors being duration of treatment and cumulative dose; mortality rates were high both in those with [89%] and without [76%] liver injury). 42277713

## OTHER REFERENCE LINKS

1. Recent References on Tigecycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(tigecycline%5BNM%5D)+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver+OR+liver+diseases/CI)+AND+(%222008/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Tigecycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=tigecycline)